# About LIVERTOX^®^

LIVERTOX is a freely available website that provides up-to-date, comprehensive and unbiased information about drug induced liver injury caused by prescription and nonprescription drugs, herbal products and dietary supplements. LiverTox represents a collaborative effort by medical and scientific specialists to provide a central repository of clinical information in support of clinical and basic research on the prevention and control of drug induced liver injury. LiverTox also provides guidance to clinicians and healthcare providers on the diagnosis and management of this important cause of liver disease. LiverTox is a joint effort of the Liver Disease Research Branch of the National Institute of Diabetes and Digestive and Kidney Diseases (NIDDK) and the National Library of Medicine (NLM), National Institutes of Health. The authors of LiverTox welcome any and all comments, particularly corrections or additions. The website is a living textbook that will be regularly updated and improved. The text of LiverTox is not copyright protected and its general use is encouraged. LiverTox can be referenced as a website: livertox.nih.gov/ or ncbi.nlm.nih.gov/books/NBK547852/ [date accessed].

## LiverTox Components

LiverTox has two major components:

- Introduction and overview of drug induced liver injury
- Specific drug records that provide concise data on the hepatotoxicity of medications, herbals and dietary supplements

The Introductory Section provides an overview of drug induced liver injury, diagnostic criteria, assessment of causality and severity, descriptions of different clinical patterns (phenotypes), information on diagnosis, management and treatment, and standardized nomenclature. The role of liver biopsy and major histological patterns of drug induced liver disease are also given.

Drug Records are the central component of LiverTox. These records provide concise descriptions of the hepatotoxicity of individual agents. A search box on the LiverTox Home Page directs users to specific drug, herbal product or dietary supplement records. The agents covered are those that are currently approved or available in the United States. With few exceptions, marketed drugs that were subsequently withdrawn or no longer produced, and drugs that are available only abroad are not discussed. Drugs covered in LiverTox are those with systemic absorption and, thus, theoretically capable of reaching and affecting the liver. Drugs that have been implicated in causing liver injury as well as those that have not been implicated and are unlikely to cause injury are included. Topical or locally applied creams and lotions, nasal sprays, eye and ear drops are not included. In addition, vaccines, plasma products, diagnostic reagents, radiology dyes, and agents with very special and limited use are generally not discussed. As of 2019, over 1200 agents are described and indexed.

## Drug Record Format

In LiverTox, each agent is discussed in a formulaic manner summarizing currently available information derived from the published literature.

### Introduction

The drug record begins with an introduction describing the agent, what it is used for, and whether it causes liver injury.

### Background

Information is next provided about the agent's class and chemical structure, mechanism of action, efficacy, when it was approved for use in the United States, its current frequency of use, indications and common "off-label" uses, available forms of the medication, brand names, recommended dosages and most common side effects. Importantly, this background information is provided only to introduce the issue of liver injury and should not be used for prescribing information or interpreted as a complete discussion of efficacy and safety.

### Hepatotoxicity

A short description is provided about the hepatotoxicity associated with the agent, the rate of serum enzyme elevations during use, and the frequency and character of the clinically apparent liver injury associated with the medication. The description of injury includes the time to onset, pattern of serum enzyme elevations, immunoallergic or autoimmune features, time to recovery and spectrum of severity. If several forms of hepatotoxicity from the medication exist, each is described separately.

This section concludes with a "likelihood score" which ranges through E (unlikely), to E* (unproven but suspected), D (possible), C (probable), B (highly likely) or A (definite likelihood of causing clinically apparent liver injury). These likelihood scores are based upon the published literature or documentation from FDA websites. They provide a rough guide of the frequency of reported instances of clinically apparent liver injury from the agent.

### Mechanism of Liver Injury

A short paragraph describes current understanding of the mechanism of liver injury.

### Outcome and Management

The introductory material concludes with a brief discussion about the range of severity of injury, whether acute liver failure or chronic injury occurs, information on management and treatment, and whether rechallenge or switching to another related agent is appropriate.

### Case Reports

The introductory material in the record is followed by one or more case studies of drug induced liver injury caused by the agent which are derived from the literature or from clinical databases, such as data maintained by the Drug Induced Liver Injury Network or files from the Clinical Center of the National Institutes of Health. The clinical examples are presented in a formulaic manner, including the important clinical, laboratory, radiologic and histologic findings, and a short concluding discussion and comment.

### Chemical and Product Information

Each substance-specific record also includes a diagram of the chemical structure, chemical formula, and links to FDA approved product information (package insert), if available.

### References

The drug record concludes with a comprehensive bibliography of references prepared principally from searches of PubMed and textbooks on hepatotoxicity. Each reference is briefly annotated and links to PubMed are provided. The references provided include case reports and case series on drug induced liver injury as well as large clinical trials or post marketing studies of safety in humans. Mechanistic studies and articles on animal models are not included in the references, unless they are directly applicable to the clinical syndrome that occurs in humans. The references are updated on an every 3- to 4-year basis.

## Status of LiverTox Development

At the time of the first release of LiverTox (April 2012), approximately 600 drug records were completed and during the first 3 years of its availability another 250 records were added. As of 2019, approximately 1200 records were available. The initial records represented the most common causes of drug induced liver injury and the most commonly used prescription drugs. Thereafter classes of drugs were completed and toxic agents, herbal products, nutritional supplements and illicit agents were added. Current plans are for LiverTox to be updated with newly approved medications and newly published articles from the literature on an every 3 to 4- year basis. By 2019, the Liver website had more than 26,000 annotated references, 400 clinical cases and greater than 2 million words.

## Writing LiverTox

### Authorship and Database Creation

The LiverTox website is the product of a large effort by many individuals over several years. LiverTox is authored by members of the Liver Disease Research Branch of the Division of Digestive Diseases and Nutrition of the National Institute of Diabetes and Digestive and Kidney Diseases (NIDDK), and the website was developed by members of the National Library of Medicine (NLM), NIH. The primary responsibility for the writing of LiverTox fell to Dr. Jay H. Hoofnagle, Chief of the Liver Diseases Research Branch. Major writing was also supplied by Dr. Victor J. Navarro, Professor of Medicine in the Hepatology Division, Thomas Jefferson University, Philadelphia, Pennsylvania (currently Chief, Division of Hepatology and Liver Transplantation, Einstein Healthcare Network, Philadelphia). Some section drafts were prepared by summer students who are now physicians, including Drs. Gramen Tontchev and Steven Harris, Jr., as well as by Drs. Jose Serrano and Leonard B. Seeff of the Liver Diseases Research Branch. The histology sections and photomicrographs were provided by Dr. David E. Kleiner of the Laboratory of Pathology, National Cancer Institute, NIH. The major editing and proofing of text and addition of links was done by Dr. James E. Knoben of the NLM with support from the NLM staff. Development of the website was primarily the responsibility of the technology team of the Biomedical Files Implementation Branch, Specialized Information Services Division, NLM. The Case Registry and interactive sections of LiverTox were developed by the technology team of the Computer Technology Branch, NIDDK, based upon a design developed by Drs. Jose Serrano and Jay Hoofnagle of the NIDDK. Secretarial and administrative help was provided by Mrs. Gina Bethea, NIDDK. In 2019, the LiverTox website was migrated to the platform Bookshelf maintained by the National Center for Biotechnology Information, NLM. At that time, an external expert review committee was established to provide scientific oversight of the LiverTox content and peer review of new content and updates of drug records. Dr. Jay Hoofnagle continues as the senior editor of LiverTox. Dr. James Knoben was appointed the deputy editor and Ms. Marge Worrest was appointed as the administrative assistant for LiverTox. (See Editors and Review Committee (https://www.ncbi.nlm.nih.gov/books/NBK548242/) for further information.)

### Reviewers

All sections of LiverTox were reviewed for accuracy and completeness by at least one outside referee. Individuals who have helped with these reviews include many of the investigators of the Drug Induced Liver Injury Network (DILIN), including Drs. Paul Watkins, Robert Fontana, Naga Chalasani, Timothy Davern, Herbert Bonkovsky, Jay Talwalkar, Victor Navarro, Rajender Reddy, Andrew Stolz, Hari Conjeevaram, John McHutchison, Paul Hayashi, and Hans Tillman. Specific sections were reviewed for content by Dr. George McDonald of the Fred Hutchinson Cancer Research Center, Seattle; Dr. Einar Bjornsson of the National University Hospital of Iceland, Reykjavik; Dr. Ynto de Boer of the University of Amsterdam Academic Medical Center, the Netherlands; Drs. Mark Gorley, Mila Chernick, Theodore Nash and John Bennett of the Clinical Center of the National Institutes of Health, Drs. Jose Serrano, Edward Doo, Averell Sherker and Susan Yanovski of the Division of Digestive Diseases and Nutrition, NIDDK, and Dr. June Cai and Russell Fleischer of the Food and Drug Administration. (See Editors and Review Committee (https://www.ncbi.nlm.nih.gov/books/NBK548242/) for further information.)

The aim of LiverTox is to provide factual, accurate and unbiased information about drug-induced liver injury. For this reason, the Expert Review Committee members and External Reviewers shall provide full disclosure of potential conflicts of interest at the time of their appointment. They will update it with any changes over the course of their term or affirm in writing “no change” on an annual basis. Examples of conflict of interest might include active financial interests in a medication, ownership of stock or serving in an advisory capacity to a pharmaceutical company. This information is kept on file by the LiverTox Senior Editor and Administrative Assistant and will be used to determine if conflicts are present, prior to assigning a chapter(s) to an individual for review. Reviewers shall decline a review assignment should they be aware of a possible conflict of interest.

### Resources

Composition of LiverTox was highly dependent upon several textbooks and resources in hepatotoxicity and pharmacology. The background information on medications were extracted from the well organized and concise "Physician's Drug Handbook", 12th Edition and the comprehensive and reliable "Goodman & Gilman's The Pharmacological Basis of Therapeutics", 11th edition, edited by Laurence L. Brunton, John S. Lazo and Keith L. Parker, the 12th edition, edited by Laurence L. Brunton, Bruce Chabner and Bjorn Knollman and the 13th edition (2018) edited by Laurence L. Brunton, Ruth Hilal-Dandan and Bjorn Knollman. Background information on herbal medications was generally based on monographs from the "PDR for Herbal Medicines", 4th Edition, Thomson Healthcare Inc, Montvale, NJ, scientific editors Gruenwald J, Brendler T, Jaenicke C. The writing of a hepatotoxicity section of the drug record began with review of the section on the medication in the scholarly and invaluable textbook "Hepatotoxicity: The Adverse Effects of Drugs and Other Chemicals on the Liver" by the late Hyman J. Zimmerman, the father of modern understanding of hepatotoxicity. The extensive references provided in Dr. Zimmerman's textbook were the basis for the start of the reference section to the drug records. A similar approach was taken to the more recently published and highly useful textbook "Drug-Induced Liver Disease" [3rd edition, 2013] edited by Neil Kaplowitz and Laurie D. DeLeve, which provided a more updated survey of hepatotoxicity and further references.

Composition of the references section began with the citations in the two textbooks on hepatotoxicity, but importantly was then supplemented by a thorough search of PubMed performed by Dr. James Knoben or by NIDDK staff. Older references were also sought from the unique monograph "Drug-Induced Hepatic Injury: A Comprehensive Survey of the Literature on Adverse Drug Reactions up to January 1985" by B. H. Ch. Stricker and P. Spoelstra. Finally, references were sought from other references during their annotation for LiverTox. Using the information from the references and the discussion from the hepatotoxicity textbooks, the sections on hepatotoxicity, mechanisms of injury, and outcome and management were composed. Help in translating articles in the literature was provided by Drs. Solko Schalm, Erasmus University, Rotterdam; Cihan Yurdaydin, Ankara University, Turkey; Barbara Rehermann, Yaron Rotman, Jose Serrano, Su Hyung Park, Yun Ju Kim and Zhensheng Zhang, NIDDK. Valuable websites used in development and writing of LiverTox included those for PubMed, DailyMed, the FDA, CDC, NIAID, and NCI. The product labels of drugs available on DailyMed and the FDA were used to verify current indications and reported adverse reactions. For recently approved medications, the FDA review of efficacy and safety was used, available on the FDA website: https://www.accessdata.fda.gov/scripts/cder/daf/. Pronunciation of drug names was based upon information from the USP Dictionary of USAN and International Drug Names, U.S. Pharmacopeia. Invaluable assistance was provided by the NIH Library in providing electronic copies of thousands of publications not available at journal websites.

### Case Reports

Cases representative of the hepatotoxicity of the medications were included in each drug record if available. As of 2019, approximately 430 case reports are provided in LiverTox. These case reports were sought from several sources, including the published literature, the database of the Drug Induced Liver Injury Network and individual cases seen at the Clinical Center of the National Institutes of Health. The cases are actual and not fabricated or modified in content. All cases are described in a formulaic fashion and those from the literature were often rearranged and simplified. Except for age and sex, no personal or identifying information is given. Cases were selected that were fully described, provided serial laboratory results (sometimes estimated from published figures) and adequately excluded other causes of liver injury. In some instances, however, no cases that satisfied these criteria were available. Furthermore, cases from the older literature often lacked important information in establishing causality in drug induced liver injury, such as testing for hepatitis A, B, C and E or modern imaging of the hepatobiliary system or even serum ALT levels. Unfortunately, case reports of drug induced liver injury are often not published unless the injury is considered "new." Furthermore, published clinical cases are often poorly described and without adequate causality assessment and exclusion of other causes. The publication bias for new or unusual forms of injury causes significant gaps. For instance, there have been no individual case reports of acetaminophen or aspirin hepatotoxicity published in the last 40 years, and few and spotty reports of hepatotoxicity of important agents such as erythromycin, tetracycline, amoxicillin, penicillin, and phenytoin. The publication bias in cases of drug induced liver injury has been a long-term problem making assessment of frequency of hepatotoxicity difficult to estimate.

The purpose of the LiverTox website is to provide clear and unbiased information on drug induced liver injury to support clinical management of patients and to stimulate interest and research directed at the prevention or treatment of this important form of liver disease.

This website is dedicated to the memory of those persons with drug induced liver injury who did not survive.

## What’s New

Survey Results Summary 2022